# Chloramphenicol

## OVERVIEW

### Introduction

Chloramphenicol is a broad spectrum antibiotic introduced into clinical practice in 1948, but which was subsequently shown to cause serious and fatal aplastic anemia and is now used rarely and reserved for severe, life-threatening infections for which other antibiotics are not available. Chloramphenicol has also been linked to cases of acute, clinically apparent liver injury with jaundice, largely in association with aplastic anemia.

### Background

Chloramphenicol (klor" am fen' i kol) is an antibiotic initially isolated from Streptomyces venezuelae and later characterized biochemically and synthesized. Chloramphenicol was introduced into clinical practice in 1948 under the brand name Chloromycetin and became a widely used antibiotic because of its oral availability, excellent tolerability and wide spectrum of activity. Chloramphenicol has bacteriostatic activity against many gram positive and gram negative organisms, both aerobic and anaerobic including H. influenza, N meningitides, S. pneumoniae, N gonorrhoeae, Brucella species and Bordetella pertussis. It also has activity against many spirochaetes, rickettsiae, chlamydiae and mycoplasmas. Chloramphenicol is thought to act by binding to the 50S ribosomal subunit in bacteria, thus inhibiting bacterial protein synthesis. A similar inhibition of protein synthesis may occur in mitochondria. Within a few years of its introduction, chloramphenicol was linked to rare cases of aplastic anemia and later to other fatal blood dyscrasias including thrombocytopenia, neutropenia and pure red cell aplasia. In addition, cases of leukemia were identified in children who had recovered from blood dyscrasias attributed to chloramphenicol. By the early 1960s, more than 1000 cases of severe bone marrow aplasia were attributed to use of chloramphenicol and it was widely banned or placed under restrictions, particularly in children. Currently, chloramphenicol is available only in parenteral forms, and its use is restricted to severe, life-threatening infections for which no other antibiotic is available because of antibiotic resistance or drug allergy. Several generic forms of chloramphenicol for intravenous administration are available and the recommended dose is 50 mg/kg daily in 4 divided doses. Monitoring for blood counts is recommended and prompt discontinuation for any evidence of myelosuppression.

### Hepatotoxicity

A proportion of patients with blood dyscrasias due to chloramphenicol also developed clinically apparent liver injury with jaundice, usually occurring before the appearance of aplastic anemia or severe thrombocytopenia. Jaundice arises in 10% to 25% of cases of aplastic anemia, usually within 1 to 2 months of starting chloramphenicol and often shortly after it is stopped. Aplastic anemia and the accompanying liver injury occur most frequently in patients who receive multiple courses of chloramphenicol or prolonged therapy. The serum enzyme pattern is usually hepatocellular and the clinical presentation is an acute hepatitis-like syndrome with onset of fatigue, nausea, anorexia and abdominal discomfort followed by dark urine and jaundice. Rare instances have a cholestatic pattern of presentation with jaundice and itching and prominent elevations in alkaline phosphatase. Some cases occur in the absence of bone marrow involvement. Immunoallergic and autoimmune features are rarely present. The course is self-limited in most instances, but examples of acute liver failure have been reported, particularly in patients without aplastic anemia. In most cases, however, the liver injury associated with chloramphenicol use is eclipsed by the severe bone marrow aplasia.

Likelihood score: B (highly likely cause of clinically apparent liver injury, now rarely seen).

### Mechanism of Injury

The etiology of liver injury associated with chloramphenicol is likely idiosyncratic and probably immunological. The hepatitis that accompanies chloramphenicol induced aplastic anemia is similar to the hepatitis that occurs with spontaneous or idiopathic aplastic anemia, suggesting a common pathogenesis of bone marrow and hepatic progenitor cell injury and loss. The marrow toxicity of chloramphenicol has been attributed to the nitrophenyl group in the molecule which is unique among microbial derived antibiotics.

### Outcome and Management

The liver injury accompanying blood dyscrasias caused by chloramphenicol is often severe, but resolves rapidly in most cases only to be followed by signs and symptoms of bone marrow failure. Acute liver failure can result, but the role of liver transplantation in this situation is difficult because of the accompanying marrow damage and aplasia.

Drug Class: Antiinfective Agents, Miscellaneous

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chloramphenicol – Generic, Chloromycetin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Chloramphenicol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Chloramphenicol | 56-75-7 | C11-H12-Cl2-N2-O5 | Chloramphenicol chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 24 January 2017

Zimmerman HJ. Chloramphenicol. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. pp 589-92. (Expert review of hepatotoxicity published in 1999 mentions that the hepatic injury from chloramphenicol is eclipsed by its vastly more important myelotoxicity, but that at least 25 cases of liver injury with jaundice have been reported, usually with hepatocellular injury).
Moseley RH. Antibacterial and Antifungal Agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 463-81. (Review of hepatotoxicity of antibiotics; chloramphenicol is not discussed).
MacDougall C, Chambers HF. Chloramphenicol. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1526-9. (Textbook of pharmacology and therapeutics).
Rich ML, Ritterhoff RJ, Hoffmann RJ. A fatal case of aplastic anemia following chloramphenicol (chloromycetin) therapy. Ann Intern Med 1950; 33: 1459-67. (63 year old man developed purpura 3 months after starting chloramphenicol, with subsequent aplastic anemia and death 2 weeks later; no mention of liver injury or jaundice). 14790529
Volini IF, Greenspan I, Ehrlich L, Gonner JA, Felsenfeld O, Schwartz SO. Hemopoietic changes during administration of chloramphenicol (chloromycetin). J Am Med Assoc 1950; 142: 1333-35. (Three African-American males developed reversible granulocytopenia during chloramphenicol therapy despite beneficial response to the antibiotic). 15412135
Winternitz C. Fatal aplastic anemia following chloramphenicol (chloromycetin) therapy. Calif Med 1952; 77: 335-9. (35 year old woman developed fatigue followed by jaundice one month after starting chloramphenicol [bilirubin 14.3 mg/dL, ALT and Alk P not available], with subsequent appearance of petechiae and aplastic anemia resulting in death within the next 3 weeks). 13009486
Rheingold JJ, Spurling CL. Chloramphenicol and aplastic anemia. J Am Med Assoc 1952; 119 (14): 1301-4. (5 cases of fatal aplastic anemia developed in 4 women and one man, ages 18-36 years, who had taken chloramphenicol within the previous two months, none with hepatitis or jaundice). 14938166
Sturgeon P. Fatal aplastic anemia in children following chloramphenicol (chloromycetin) therapy; report of four cases. J Am Med Assoc 1952; 149: 918-22. (4 children were admitted to a Los Angeles referral hospital over a 2 year period with aplastic anemia after chloramphenicol treatment, ages 2-6 years, 2-6 weeks after course of chloramphenicol resulting in fatal outcome, no mention of liver injury or jaundice). 14938069
Claudon DB, Holbrook AA. Fatal aplastic anemia associated with chloramphenicol (chloromycetin) therapy; report of two cases. J Am Med Assoc 1952; 149: 912-4. (71 year old woman and 92 year old man developed aplastic anemia 2 and 6 weeks after multiple courses of chloramphenicol with fatal outcomes and aplasia of marrow; no mention of hepatitis or jaundice). 14938067
Hargraves MM, Mills SD, Heck FJ. Aplastic anemia associated with administration of chloramphenicol. J Am Med Assoc 1952; 119: 1293-1300. (Description of 10 cases of aplastic anemia possibly attributable to use of chloramphenicol: latency 1-6 weeks, often with prolonged, intermittent or multiple courses, five in children, 7 fatal, one with jaundice preceding onset of petechiae and subsequent aplastic anemia). 14938165
Hargraves MM. Aplastic anemia associated with the administration of chloramphenicol. Proc Staff Meet Mayo Clin 1952; 27: 280-1. (Further information on 6 cases of aplastic anemia attributed to chloramphenicol [Hargraves 1952], most of which were fatal, precipitous in onset and not responsive to corticosteroid or vitamin B12 administration). 14941875
Smiley RK, Cartwright GE, Wintrobe MM. Fatal aplastic anemia following chloramphenicol (chloromycetin) administration. J Am Med Assoc 1952; 149: 914-8. (3 cases of fatal aplastic anemia in one 29 year old man and two young girls [6 and 8 years old] arising within a few weeks of exposure to chloramphenicol [all with prolonged or intermittent courses], without jaundice or liver injury). 14938068
Hawkins LA, Lederer H. Fatal aplastic anaemia after chloramphenicol treatment. Br Med J 1952; 2 (4781): 423-6. (Two girls, ages 4 and 7, developed jaundice 39 and 49 days after starting 27- and 44-day courses of chloramphenicol for whooping cough [liver tests not provided] which lasted for a few days and was followed by bruising and progressive, ultimately fatal aplastic anemia). 14944846
Wolman B. Fatal aplastic anaemia after chloramphenicol. Br Med J 1952; 2 (4781): 426-7. (6 year old developed fatigue and jaundice followed by bruising one month after finishing a 24 day course of chloramphenicol [bilirubin, ALT and Alk P not given], with subsequent aplastic anemia and death within a month; at autopsy the liver was enlarged and showed fatty change). 14944847
Salm R. Acute necrosis of the liver following chloramphenicol therapy. Edinb Med J 1953; 60: 334-6. 13060295
Hodgkinson R. Blood dyscrasias associated with chloramphenicol. An investigation into the cases in the British Isles. Lancet 1954; 266 (6806): 285-7. (Mailed survey identified 31 cases of blood dyscrasias arising after administration of chloramphenicol in the UK, 28 aplastic anemia, 3 granulocytopenia, 8 [26%] preceded by jaundice, in all ages, 11 children, 13 male and 18 female, 24 fatal). 13131842
Abbott VC, Marra JJ, Gell JW. Acute yellow atrophy of the liver following chloramphenicol (chloromycetin) therapy. J Mich State Med Soc 1955; 54: 474-6. (53 year old woman developed jaundice and rapidly fatal acute liver failure after a second prolonged course [~2 months] of oral chloramphenicol [bilirubin and liver tests not given], without evidence of aplastic anemia). 14368249
Cable JV, Reid JD. Jaundice and aplastic anaemia following chloramphenicol therapy. N Z Med J 1957; 56: 532-5. (14 year old girl developed jaundice shortly after a 30 day course of chloramphenicol for acne [bilirubin 60 mg/dL, ALT not available, Alk P normal], which resolved over the next month, followed by easy bruising and evidence of aplastic anemia which led to death one month later). 13483950
Brunton L, Shapiro L. Chloramphenicol and aplastic anemia: report of four cases. Can Med Assoc J 1962; 86: 863-5. (Four cases of aplastic anemia developing in 3 men and one woman, ages 40-81 years, presenting with bleeding, having received chloramphenicol within the previous two months, 3 fatal, no mention of jaundice or hepatitis). 13874077
Foot EC, Thomson WB. Cholestatic jaundice after chloramphenicol. Br Med J 1963; 1 (5327): 403-4. (54 year old man developed jaundice two months after starting intermittent chloramphenicol for urinary tract infections [bilirubin 19 mg/dL, ALT 305 U/L, Alk P 2.3 times ULN], with subsequent pancytopenia and death from sepsis). 13958656
Gjone E, Orning OM. Jaundice due to chloramphenicol. Acta Hepatosplenol 1966; 13: 288-92. (25 year old woman developed fatigue followed by jaundice on 4 occasions over a four year period [AST 210, 2160, 2120 and 426, Alk P twice normal], each episode preceded by a course of chloramphenicol). 5994989
Rubin E, Gottlieb C, Vogel P. Syndrome of hepatitis and aplastic anemia. Am J Med 1968; 45: 88-97. (Description of 9 cases of jaundice followed by pancytopenia and aplasia of unknown cause, suspected to be due to a form of viral hepatitis). 5658873
Wallerstein RO, Condit PK, Kasper CK, Brown JW, Morrison FR. Statewide study of chloramphenicol therapy and fatal aplastic anemia. JAMA 1969; 208: 2045-50. (Review of death certificates and pharmacy records in California over 18 month period identified 60 deaths attributed to aplastic anemia, among whom 8 had recently received chloramphenicol representing a risk for aplastic anemia of ~1 per 36,000 persons exposed to chloramphenicol). 5818983
Furuyama M, Matsuda I. Chloramphenicol and jaundice in a baby. Lancet 1967; 2 (7511): 366-7. (2 month old child developed jaundice 16 days after starting intramuscular injections of chloramphenicol [bilirubin ~4-5 mg/dL, ALT 40-75 U/L, Alk P not given], resolving rapidly after stopping antibiotic). 4143738
Polak BC, Wesseling H, Schut D, Herxheimer A, Meyler L. Blood dyscrasias attributed to chloramphenicol. A review of 576 published and unpublished cases. Acta Med Scand 1972; 192: 409-14. (Analysis of 576 cases of blood dyscrasias attributed to chloramphenicol, 70% had pancytopenia, mortality was independent of age or sex; no mention of liver injury or jaundice). 5083381
Hodgkinson R. The chloramphenicol--hepatitis--aplastic anaemia syndrome. Med J Aust 1973; 1: 939-40. (Five cases of aplastic anemia and hepatitis, presenting with fatigue and jaundice with aplastic anemia arising during recovery, but resulting in death over long term). 4715401
Ito M, Fukuiya Y. [Hepatitis-aplastic anemia syndrome (after the administration of chloramphenicol) (author's transl)]. Rinsho Ketsueki 1974 Sep; 15 (9): 985-92. (32 year old woman developed jaundice 4 weeks after a 4 week course of chloramphenicol [bilirubin 25.2 mg/dL, ALT 1100 U/L, Alk P 1.2 times ULN], resolving over the next few weeks, but then developing thrombocytopenia followed by fatal aplastic anemia). 4612200
Shibata A, Fukuda M. [Chloramphenicol-hepatitis-aplastic anemia syndrome]. Nihon Rinsho 1977; 35 Suppl 1: 970-1. Japanese. 613075
Casale TB, Macher AM, Fauci AS. Complete hematologic and hepatic recovery in a patient with chloramphenicol hepatitis-pancytopenia syndrome. J Pediatr 1982; 101: 1025-7. (15 year old boy with chronic granulomatous disease developed fever and liver injury 18 days after starting chloramphenicol for C. violaceum sepsis [bilirubin normal, ALT ~150 U/L, GGT 1160 U/L, platelets 50,000], recovering promptly with stopping). 7143157
Yunis AA. Chloramphenicol toxicity: 25 years of research. Am J Med 1989 Sep; 87 (3N): 44N-48N. (Review of the metabolism of chloramphenicol and its toxicity to bone marrow elements leads to the hypothesis that a toxic metabolite of the drug is responsible for damage and loss of marrow stem cells). 2486534
Doona M, Walsh JB. Use of chloramphenicol as topical eye medication: time to cry halt? BMJ 1995; 310 (6989): 1217-8. (Editorial suggesting avoidance of use of ophthalmologic chloramphenicol because of the rare, but fatal complication of aplastic anemia, at least 5 cases of which are described in the literature). 7767184
Rayner SA, Buckley RJ. Ocular chloramphenicol and aplastic anaemia. Is there a link? Drug Saf 1996; 14: 273-6. (Review of the evidence for and against the association of chloramphenicol eye drops and aplastic anemia). 8800624
Wiholm BE, Kelly JP, Kaufman D, Issaragrisil S, Levy M, Anderson T, Shapiro S. Relation of aplastic anaemia to use of chloramphenicol eye drops in two international case-control studies. BMJ 1998; 316 (7132): 666. (Analyses of registries from two international case control studies of aplastic anemia found none of 426 cases [but 7 of 3118 controls] had a recent history of use of chloramphenicol eye drops). 9522791
Lancaster T, Swart AM, Jick H. Risk of serious haematological toxicity with use of chloramphenicol eye drops in a British general practice database. BMJ 1998; 316: 667. (Among 442,543 patients who received chloramphenicol eye drops over a 7 year period in the UK, 3 patients had a subsequent diagnosis of severe hematologic toxicity within the following 3 months, but in each case an alternative diagnosis was possible and the maximal calculated risk was <1 per 100,000 persons exposed). 9522792
Wareham DW, Wilson P. Chloramphenicol in the 21st century. Hosp Med 2002; 63 (3): 157-61. (Review of the current status of chloramphenicol as an antiinfective agent as well as its spectrum of activity, mechanism of action, pharmacokinetics, adverse effects, interactions and clinical uses). 11933819
Doshi B, Sarkar S. Topical administration of chloramphenicol can induce acute hepatitis. BMJ 2009; 338: 1699. (37 year old man developed fatigue and jaundice, 1 week after a 5 day course of chloramphenicol eye drops [bilirubin 1.9 mg/dL, AST 868 U/L, Alk P 224 U/L], resolving over the next 10 months). 19525305

## OTHER REFERENCE LINKS

1. Recent References on Chloramphenicol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Chloramphenicol/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Chloramphenicol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chloramphenicol)